# Succimer

## OVERVIEW

### Introduction

Succimer is an oral heavy metal chelating agent used to treat lead and heavy metal poisoning. Succimer has been linked to a low rate of transient serum aminotransferase elevations during therapy, but its use has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Succimer (sux’ i mer) or dimercaptosuccinic acid (DMSA) is an orally available heavy metal chelating agent that is used to treat lead poisoning in children. Succimer is an organo-sulfur compound with two sulfhydryl groups that bind divalent metal ions such as lead, cadmium, mercury, and arsenic. Succimer does not significantly chelate essential metals such as zinc, copper or iron, and its specificity, safety and oral availability make it preferable to other chelating agents for treating lead poisoning such as Ca-EDTA which must be given intravenously and dimercaprol (British anti-Lewisite [BAL]) which requires intramuscular administration. Succimer has been shown to lower blood lead levels and improve symptoms of chronic lead poisoning. Succimer was approved for use in the United States in 1991, and current indications are for treatment of lead poisoning in pediatric patients with plasma lead levels above 45 µg/dL. It is used off label to treat adults with lead poisoning and for therapy of arsenic and mercury intoxication. Succimer is also used in naturopathic medicine administered orally as well as intravenously as a part of chelation therapy for various conditions. Succimer is available in capsules of 100 mg generically and under the brand name Chemet. The recommended dose is 10 mg/kg (or 350 mg/m^2^) every 8 hours for 5 days, and reduce to every 12 hours for an additional 2 weeks of therapy, with a minimum 2 week rest period between repeated courses if lead levels remain high. Side effects are generally mild and may include headache, nausea, anorexia, diarrhea, rash, neutropenia and renal dysfunction. Uncommon, but potentially severe adverse events include hypersensitivity reactions. Intravenous administration of succimer as used in naturopathic medicine has not been approved for any indication and has been associated with sudden death attributed to hypocalcemia.

### Hepatotoxicity

In clinical trials conducted in children with lead poisoning, serum aminotransferase levels elevations occurred in 7% of succimer- vs 4% of placebo-treated subjects. However, ALT levels above 5 times the upper limit of normal were rare (<1% of treated patients) and no child had to stop therapy early because of liver test abnormalities. There have been no clinical reports of liver injury with jaundice attributed to succimer, but it has had limited general clinical use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during succimer therapy is not known. Succimer-metal chelates are eliminated in the urine.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Succimer has not been implicated in cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. Despite the lack of evidence of significant liver injury from succimer, the product label recommends routine liver testing before and every week during therapy. There does not appear to be cross reactivity in risk for hepatic injury between succimer and other chelating agents including deferoxamine or deferiprone.

Drug Class: Chelating Agents, Lead Chelators

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Succimer – Generic, Chemet®

DRUG CLASS

Chelating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Succimer)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Succimer | 304-55-2 | C4-H6-O4-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 August 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999; succimer is not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; chelating agents are not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1311-15. (Textbook of pharmacology and therapeutics).
Graziano JH, Lolacono NJ, Moulton T, Mitchell ME, Slavkovich V, Zarate C. Controlled study of meso-2,3-dimercaptosuccinic acid for the management of childhood lead intoxication. J Pediatr 1992; 120: 133-9. (Among 19 children with high blood lead levels [50-69 µg/dL], succimer lowered levels by 61% which was more than achieved with intravenous Ca-EDTA [45%], and repeated courses of succimer prevented the rebound that typically occurs after a single course of therapy; one child had a transient minor increase in ALT levels [26 to 62 U/L]). 1309865
Glotzer DE. The current role of 2,3-dimercaptosuccinic acid (DMSA) in the management of childhood lead poisoning. Drug Saf 1993; 9: 85-92. (Review of the mechanism of action, efficacy and safety of succimer as a chelating agent for lead poisoning mentions that its safety profile is encouraging, but its use has been limited and its efficacy in preventing neurotoxicity from lead poisoning remains unproven). 8397892
Miller AL. Dimercaptosuccinic acid (DMSA), a non-toxic, water-soluble treatment for heavy metal toxicity. Altern Med Rev 1998; 3: 199-207. (Review of heavy metal poisoning from lead, mercury, arsenic and cadmium and the role of succimer therapy). 9630737
Guha Mazumder DN, Ghoshal UC, Saha J, Santra A, De BK, Chatterjee A, Dutta S, et al. Randomized placebo-controlled trial of 2,3-dimercaptosuccinic acid in therapy of chronic arsenicosis due to drinking arsenic-contaminated subsoil water. J Toxicol Clin Toxicol 1998; 36: 683-90. (Among 21 patients with chronic arsenic toxicity due to drinking water contamination in West Bengal, there were no differences between succimer and placebo therapy in changes in symptoms or arsenic levels after 2 two-week courses). 9865236
Safety and efficacy of succimer in toddlers with blood lead levels of 20-44 microg/dL. Treatment of Lead-Exposed Children (TLC) Trial Group. Pediatr Res 2000; 48: 593-9. (Among 780 children, ages 1-3 years, with moderately elevated blood lead levels [20-44 µg/dL] treated with up to 3 courses of succimer or placebo, there was no excess of any adverse event in either group, Alk P elevations occurred in 39% of both groups, ALT elevations greater than 2 times ULN occurred in 0.8% of succimer- and 1.1% in placebo-recipients, but were transient and confirmed on repeat testing in only 1 child). 11044477
Chisolm JJ Jr. Safety and efficacy of meso-2,3-dimercaptosuccinic acid (DMSA) in children with elevated blood lead concentrations. J Toxicol Clin Toxicol 2000; 38: 365-75. (Among 59 children given 116 four-week courses of succimer for lead toxicity, lead levels fell rapidly on treatment, but rebounded to 58% of pretreatment values thereafter; there were no adverse reactions). 10930052
Centers for Disease Control and Prevention (CDC). Deaths associated with hypocalcemia from chelation therapy--Texas, Pennsylvania, and Oregon, 2003-2005. MMWR Morb Mortal Wkly Rep 2006; 55: 204-7. (Description of 3 cases of sudden death from hypocalcemia caused by intravenous administration of Na2-EDTA as chelation for lead poisoning or as naturopathic chelation therapy to remove heavy metals; the patient with lead poisoning was also receiving oral succimer, and Na2-EDTA was mistakenly given instead of Ca-EDTA). 16511441
Adams JB, Baral M, Geis E, Mitchell J, Ingram J, Hensley A, Zappia I, et al. Safety and efficacy of oral DMSA therapy for children with autism spectrum disorders: Part A--medical results. BMC Clin Pharmacol 2009; 9: 16. (Among 65 children with autism spectrum disorder, ages 3 to 8 years, treated with up to 9 three-day cycles of succimer therapy, urinary excretion of lead, tin, copper, manganese and bismuth increased significantly, and there was no significant change in any blood chemistry result). 19852789
Kosnett MJ. The role of chelation in the treatment of arsenic and mercury poisoning. J Med Toxicol 2013; 9: 347-54. (Review of the history, chemical structure, mechanism of action, preclinical and clinical assessment of the dithiol chelating agents, dimercaprol [BAL: British anti-Lewisite] and its two water soluble derivatives, dimercaptopropane sulfonic acid [DMPS, unithiol] and dimercaptosuccinic acid [DMSA: succimer] for their ability to chelate and lead to redistribution and secretion of arsenic, mercury and other heavy metals). 24178900
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to succimer). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to succimer or other chelating agents). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to succimer or other chelating agents). 25754159
Breyre A, Green-McKenzie J. Case of acute lead toxicity associated with Ayurvedic supplements. BMJ Case Rep 2016; 2016: bcr2016215041. (26 year old man developed abdominal pain and anemia after having taken Ayurvedic medications for back pain for 4 months, blood lead levels 94.8 µg/dL treated with succimer in 4 courses which lowered levels rapidly to normal, bilirubin and ALT levels were “mildly” elevated initially but resolved with control of abdominal pain before starting succimer).
Grasso IA, Blattner MR, Short T, Downs JW. Severe systemic lead toxicity resulting from extra-articular retained shrapnel presenting as jaundice and hepatitis: a case report and review of the literature. Mil Med 2017; 182: e1843-e1848. (31 year old active duty military policeman developed abdominal pain, peripheral neuropathy, anemia, weakness and jaundice, having sustained severe gunshot wounds 9 years earlier with residual shrapnel in his upper thigh, who was eventually found to have elevations in blood lead levels [125 µg/mL] and who eventually improved with chelation therapy, first BAL and EDTA followed by succimer; details of liver tests not provided). 28290970
Sakthithasan K, Lévy P, Poupon J, Garnier R. A comparative study of edetate calcium disodium and dimercaptosuccinic acid in the treatment of lead poisoning in adults. Clin Toxicol (Phila) 2018; 56: 1143-1149. (Among 34 adults with high blood lead levels [>40 µg/dL] treated with either succimer or EDTA in 2 five-day courses, reduction in lead levels was greater with succimer but clinical symptoms improved with both treatments, while asymptomatic ALT elevations [<3 times ULN] arose in 25% vs 14% of patients, resolving in all when therapy was stopped). 29889577
Wilcox MA, Hardin J, Weaver J, Voss EA. Liver test monitoring: real-world compliance for drugs with monitoring requirements at 2-week intervals or more frequently. Pharmaceut Med 2019; 33: 389-94. (Analysis of 3 large health databases for compliance with recommendations for liver test monitoring when initiating therapy with 9 drugs found compliance in 139 patients treated with succimer to be only 29% for weekly monitoring as suggested by the product label; unclear whether succimer was being used for chelation of lead in children). 31933226

## OTHER REFERENCE LINKS

1 Recent References on Succimer: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Succimer+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Succimer: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Succimer)